# Atomoxetine

## OVERVIEW

### Introduction

Atomoxetine is a selective norepinephrine reuptake inhibitor used primarily for therapy of attention deficit hyperactivity disorder. Atomoxetine has been linked to a low rate of serum aminotransferase elevations and to rare cases of acute, clinically apparent liver injury.

### Background

Atomoxetine (a" toe mox' e teen) is a selective norepinephrine reuptake inhibitor that blocks the presynaptic norepinephrine transporter leading to an increase in levels of this potent neurotransmitter, predominantly in the central nervous system. Therapy with atomoxetine has been shown to lead to improvements in levels of psychological functioning and performance in children and adults with suspected attention deficit/hyperactivity disorder (ADHD). Atomoxetine was approved for use in adults, adolescents and children above the age of 6 years with ADHD in the United States in 2002. Atomoxetine is available in capsules of 10, 18, 25, 40, 60, 80 and 100 mg in generic forms and under the brand name Strattera. The recommended initial dosage in adults is 40 mg once daily, with subsequent increases to a maintenance dose which averages 60 to 100 mg daily. The dosage in children is based upon body weight. Common side effects include headache, insomnia, irritability, dry mouth, erectile dysfunction, urinary hesitancy, gastrointestinal upset, nausea, constipation and rash. Uncommon but potential severe adverse events include suicidal ideation and behavior, cardiovascular symptoms and events, manic or aggressive behavior, priapism and hypersensitivity reactions.

### Hepatotoxicity

Atomoxetine has been linked to serum aminotransferase elevations in a small proportion of patients (~0.5%). More importantly, there have been several reports of clinically apparent acute liver injury due to atomoxetine. The onset of injury was within 3 to 12 weeks of starting the medication. The typical pattern of serum enzyme elevations was hepatocellular with marked increases in serum aminotransferase levels (often >20 times upper limit of normal) and clinical features that resembled acute viral hepatitis. Most cases have been self-limited, but instances of acute liver failure sometimes requiring emergency liver transplantation have been reported. Immunoallergic features were not found, but several patients with acute injury had antinuclear antibody and at least one patient had other features that resembled autoimmune hepatitis (with typical liver histology and high levels of immunoglobulins in serum).

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which atomoxetine might cause liver injury is unknown. Atomoxetine is extensively metabolized in the liver by the cytochrome P450 system, predominantly CYP 2D6 and production of a toxic intermediate or immunogenic byproduct are reasonable explanations. Atomoxetine is susceptible to drug-drug interactions with other substrates that use CYP 2D6 as well as inducers and inhibitors of the enzyme. Patients who have low or absent levels of CYP 2D6 (poor metabolizers) may have high plasma levels of atomoxetine and have more severe adverse events when receiving conventional doses, and those with high CYP 2D6 levels (ultrafast metabolizers) may have low plasma levels and fail to respond to treatment.

### Outcome and Management

The liver injury due to atomoxetine varies from minor, transient and asymptomatic elevations in serum aminotransferase levels to clinically apparent hepatitis that can be prolonged and even fatal. Chronic liver injury and vanishing bile duct syndrome due to atomoxetine have not been described. Atomoxetine should be discontinued if jaundice or symptoms of liver injury accompany serum enzyme elevations during treatment or if aminotransferase levels rise to above 5 times the upper limit of normal. There does not seem to be cross reactivity to hepatic injury between atomoxetine and other agents used for ADHD, but there may be cross reactivity with other norepinephrine reuptake inhibitors.

Drug Class: Central Nervous System Stimulants; ADHD Agents

## CASE REPORT

### Case 1. Acute hepatitis in a child treated with atomoxetine.(1)

A 12 year old girl with ADHD developed abdominal pain, nausea, diarrhea and jaundice three weeks after restarting atomoxetine (40 mg daily). She had no previous history of liver disease or risk factors for viral hepatitis. She had received atomoxetine for approximately one year, but stopped taking it when she ran out of the medication, leading to an interruption of therapy for 6 weeks before restarting. She was not taking any other medications, over-the-counter drugs or herbals. On examination, she was jaundiced and had mild right upper quadrant tenderness without hepatomegaly or other manifestations of chronic liver disease. She had no fever or rash. Laboratory tests showed a total bilirubin of 9.1 mg/dL (direct 5.5 mg/dL) and marked elevations in serum aminotransferase levels (ALT 3264 U/L, AST 2999 U/L), with minimal increase in alkaline phosphatase (231 U/L) and gamma glutamyl transpeptidase (108 U/L) (Table). Tests for hepatitis A, B and C were negative. Antinuclear antibody was positive in a titer of 1:160; smooth muscle antibody was negative. There was no hypergammaglobulinemia, and total IgG levels were normal (769 mg/dL). A liver biopsy showed focal hepatocyte necrosis and marked portal and parenchymal inflammatory infiltrates, with minimal fibrosis and normal bile ducts. Atomoxetine was discontinued and she was monitored on no specific therapy. She improved markedly over the next six weeks, and liver tests were normal when tested six months later.

#### Key Points

Medication: | Atomoxetine (40 mg daily)
Pattern: | Hepatocellular (R=39)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 weeks (reexposure)
Recovery: | ~6 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | | Atomoxetine (40 mg daily) started
3 weeks | 0 | 1979 | 363 | 8.0 | Atomoxetine stopped
5 weeks | 2 weeks | | | 9.8 | Liver biopsy
7 weeks | 4 weeks | 1438 | 177 | 2.6
9 weeks | 6 weeks | 107 | 182 | 1.6
7 months | 6 months | <15 | 176 | 0.3
Normal Values | | <50 | <397 | <1.2

#### Comment

A young girl who had previously taken atomoxetine without difficulty developed an acute, self-limited hepatitis 3 weeks after restarting it. The hepatitis was accompanied by autoantibody formation, but without elevations in globulins or IgG levels. She improved upon stopping atomoxetine and corticosteroids were not used. Drug induced liver injury due to atomoxetine is rare, but several instances of an acute hepatitis-like syndrome arising within 3 to 12 weeks of starting or restarting the medication have been reported in patients without any other obvious reason for acute liver injury. The injury is usually hepatocellular with markedly elevated serum aminotransferase levels (as in this case). Recurrence with reexposure has been reported and should be avoided.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Atomoxetine – Generic, Strattera®

DRUG CLASS

Central Nervous System Stimulants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Atomoxetine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Atomoxetine | 82248-59-7 | C17-H21-N-O.Cl-H

## CITED REFERENCE

1 Lim JR, Faught PR, Chalasani NP, Molleston JP. (2006). Severe liver injury after initiating therapy with atomoxetine in two children. J Pediatr.

## ANNOTATED BIBLIOGRAPHY

References updated: 25 August 2021

Abbreviations: ADHD, attention deficit/hyperactivity disorder.

Zimmerman HJ. Psychotropic and anticonvulsant agents. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-516. (Expert review of hepatotoxicity published in 1999; atomoxetine is not mentioned).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants; atomoxetine is not discussed).
O'Donnell JM, Shelton RC. Pharmacotherapy of depression and anxiety disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 397-416. (Textbook of pharmacology and therapeutics).
Simpson D, Plosker GL. (2004). Atomoxetine: a review of its use in adults with attention deficit hyperactivity disorder. Drugs. (Review of pharmacology, clinical efficacy and safety of atomoxetine in attention deficit hyperactivity disorder [ADHD]; common side effects are dry mouth, insomnia, nausea, poor appetite, constipation, dizziness, sweating, sexual dysfunction and palpitations; no mention of ALT elevations or hepatotoxicity).
Drugs for treatment of ADHD. (2006). Treat Guidel Med Lett. (Drugs approved for use in ADHD in the US include atomoxetine, amphetamines and methylphenidate; common side effects of atomoxetine include somnolence, nausea and decreased appetite; “Hepatic toxicity has been reported rarely”).
Lim JR, Faught PR, Chalasani NP, Molleston JP. (2006). Severe liver injury after initiating therapy with atomoxetine in two children. J Pediatr. (Two cases; 12 year old girl developed jaundice 3 weeks after restarting atomoxetine [bilirubin 9.1 mg/dL, ALT 3264 U/L, Alk P 231 U/L, ANA 1:160, IgG 769 mg/dL], resolving in 8 weeks of stopping [Case 1]; 11 year old girl developed fatigue 3 months after starting atomoxetine [bilirubin 0.5 mg/dL, ALT 675 U/L, Alk P 96 U/L, ANA 1:320, IgG 7,390 mg/dL] and biopsy suggesting chronic hepatitis, hepatitis improving within a few weeks of starting prednisone).
Stojanovski SD, Casavant MJ, Mousa HM, Baker P, Nahata MC. (2007). Atomoxetine-induced hepatitis in a child. Clin Toxicol (Phila). (8 year old female developed abdominal pain 1 month after starting atomoxetine [bilirubin 10.8 mg/dL, ALT 5182 U/L, Alk P 528 U/L, ANA negative], resolving within 2 months of stopping; also describes 2 cases reported to FDA: 14 year old boy and 31 year old woman developed symptoms 2.5-3.5 months after starting atomoxetine [bilirubin 1.2 and 16 mg/dL, ALT 31-36 times ULN, Alk P normal], resolving in 2-4 months).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, atomoxetine accounted for 3 cases [1%], 2 of which had been previously reported [Lim 2006]).
Bangs ME, Jin L, Zhang S, Desaiah D, Allen AJ, Read HA, Regev A, et al. (2008). Hepatic events associated with atomoxetine treatment for attention-deficit hyperactivity disorder. Drug Saf. (Review of hepatic adverse events of atomoxetine; of 7961 patients treated in clinical trials, 41 had hepatobiliary events, but most were mild increases in ALT and none had jaundice with hepatitis; since marketing, there have been 351 spontaneous reports of liver adverse events, but only 3 were considered probable, one of which had a positive rechallenge).
Garnock-Jones KP, Keating GM. (2009). Atomoxetine: a review of its use in attention-deficit hyperactivity disorder in children and adolescents. Paediatr Drugs. (Review of mechanism of action, pharmacology, clinical efficacy and safety of atomoxetine as treatment of ADHD in children; common side effects are headache, abdominal pain, decreased appetite, nausea, somnolence, fatigue, irritability and dizziness; mild elevations in ALT or AST occur in 0.5% of subjects, and the sponsor has received reports of 351 hepatic adverse events from an estimated 4.3 million recipients [<0.01%]).
Johnson M, Cederlund M, Råstam M, Areskoug B, Gillberg C. (2010). Open-label trial of atomoxetine hydrochloride in adults with ADHD. J Atten Disord. (Open label trial of atomoxetine in 20 adults with ADHD; one patient discontinued drug because of raised liver enzymes; no details given).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 2 agents used for ADHD were among the top 41 causes; methylphenidate [11th, 96 cases] and atomoxetine [14th, 64 cases]).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, one case was attributed to atomoxetine).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including one attributed to cocaine and one to ecstasy but none to atomoxetine).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N. (2011). Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, 3 were attributed to atomoxetine and one to methylphenidate).
Erdogan A, Ozcay F, Piskin E, Karaman MG, Bilezikci B, Calik M, Tekin I, et al. (2011). Idiosyncratic liver failure probably associated with atomoxetine: a case report. J Child Adolesc Psychopharmacol. (10 year old boy developed fatigue 2 days and jaundice 5 days after starting atomoxetine [bilirubin 5.2 rising to 23.0 mg/dL, ALT 942 to 2832 U/L, Alk P 400 U/L, INR 4.1], with progressive liver failure, encephalopathy and emergency living donor liver transplantation).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, Presentation and Outcomes in Patients with Drug-Induced Liver Injury in the General Population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to atomoxetine).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to atomoxetine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 [0.5%] were attributed to atomoxetine).
Cortese S, Panei P, Arcieri R, Germinario EA, Capuano A, Margari L, Chiarotti F, et al. (2015). Safety of methylphenidate and atomoxetine in children with attention-deficit/ hyperactivity disorder (ADHD): data from the Italian National ADHD Registry. CNS Drugs. (The Italian ADHD Registry of children treated with methylphenidate [n=1350] and atomoxetine [n=753] included adverse events reports in 27% of cases and serious events in 4%, more frequently with atomoxetine among which were 3 cases of hyperbilirubinemia which were considered possibly life-threatening).
Camporeale A, Porsdal V, De Bruyckere K, Tanaka Y, Upadhyaya H, Deix C, Deberdt W. (2015). Safety and tolerability of atomoxetine in treatment of attention deficit hyperactivity disorder in adult patients: an integrated analysis of 15 clinical trials. J Psychopharmacol. (Among 4829 patients enrolled in 15 placebo controlled trials of atomoxetine in adults with ADHD, rates of serious adverse events were similar in the two groups and there were no differences in changes in ALT or in numbers of liver-related serious adverse events).
Drugs for ADHD. (2015). Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs approved for use in ADHD, including atomoxetine and methylphenidate; no mention of ALT elevations or hepatotoxicity of either drug).
Dean L. Atomoxetine Therapy and CYP2D6 Genotype. 2015 Sep 10 [updated 2020 Jun 29]. In: Pratt VM, Scott SA, Pirmohamed M, Esquivel B, Kane MS, Kattman BL, Malheiro AJ, editors. Medical Genetics Summaries [Internet]. Bethesda (MD): National Center for Biotechnology Information (US); 2012–. (Atomoxetine is metabolized by CYP 2D6 and is sensitive to the effects of various variants that can create ultrafast, normal, intermediate or poor metabolizers, which can create low or high plasma levels with conventional dosages).
Goto T, Hirata Y, Takita Y, Trzepacz PT, Allen AJ, Song DH, Gau SS, et al. (2017). Efficacy and safety of atomoxetine hydrochloride in Asian adults with ADHD. J Atten Disord. (Among 391 Asian adults with ADHD treated with atomoxetine or placebo for 10 weeks, improvements in ADHD rating scores were greater with atomoxetine and adverse events included nausea, decreased appetite, drug mouth, thirst, vomiting, weight loss, dizziness and dysuria, discontinuations occurring in 5% vs 1.5% of placebo recipients; no mention of ALT elevations or hepatotoxicity).
Tumuluru RV, Corbett-Dick P, Aman MG, Smith T, Arnold LE, Pan X, Buchan-Page KA, et al. (2017). Adverse events of atomoxetine in a double-blind placebo-controlled study in children with autism. J Child Adolesc Psychopharmacol. (Among 128 children [ages 5 to 14 years] with ADHD treated with atomoxetine alone or placebo with or without parent training, adverse events linked to atomoxetine included decrease in appetite and fatigue, and "no significant difference of changes in laboratory tests was noted" between the groups).
Hinson VK, Delambo A, Elm J, Turner T. (2016). A randomized clinical trial of atomoxetine for mild cognitive impairment in Parkinson's disease. Mov Disord Clin Pract. (Among 130 adults with cognitive impairment due to Parkinson disease treated with atomoxetine or placebo for 10 weeks, global scores of attention, working memory and processing speed did not improve with atomoxetine, but adverse events were more frequent, while laboratory monitoring of “liver function did not reveal any clinically significant changes”).
Padilha SCOS, Virtuoso S, Tonin FS, Borba HHL, Pontarolo R. (2018). Efficacy and safety of drugs for attention deficit hyperactivity disorder in children and adolescents: a network meta-analysis. Eur Child Adolesc Psychiatry. (Systematic review of efficacy and safety of drugs for ADHD based upon 48 trials [4169 participants]; makes no mention of ALT elevations or hepatotoxicity of any of the agents studied, including guanfacine).
Cortese S, Adamo N, Mohr-Jensen C, Hayes AJ, Bhatti S, Carucci S, Del Giovane C, et al., European ADHD Guidelines Group (EAGG). (2017). Comparative efficacy and tolerability of pharmacological interventions for attention-deficit/hyperactivity disorder in children, adolescents and adults: protocol for a systematic review and network meta-analysis. BMJ Open. (Review of the pharmacological therapy of ADHD with discussion of amphetamines, methylphenidate, atomoxetine, guanfacine and clonidine; no mention of ALT elevations during therapy or hepatotoxicity).
Schoretsanitis G, de Leon J, Eap CB, Kane JM, Paulzen M. (2019). Clinically significant drug-drug interactions with agents for attention-deficit/hyperactivity disorder. CNS Drugs. (Review of drug-drug interactions of agents used to treat ADHD mentions that there is little information on the metabolism of clonidine and possible drug-drug interactions).
Drugs for ADHD. (2020). Med Lett Drugs Ther. (Concise review of drugs for attention deficit/hyperactivity disorder mentions that atomoxetine is a nonstimulatory agent that is less effective but sometimes better tolerated than methylphenidate, rare but severe adverse events include hepatitis [rarely] growth delay, increase in blood pressure and pulse and priapism).
Abrams M, Hasan S, Mehta A. (2021). liver enzyme elevation from atomoxetine use–a case report. J Child Adolesc Psychopharmacol. (17 year old transgender male with ADHD on long term atomoxetine was found to have mild serum aminotransferase elevations without symptoms [ALT 71 U/L initially and then 52 U/L 3 months and 19 U/L 6 months after stopping]; no information on body weight, ultrasound findings, or hepatitis serology).

## OTHER REFERENCE LINKS

1 Recent References on Atomoxetine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=atomoxetine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Atomoxetine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=atomoxetine)